# Glycopyrrolate

## OVERVIEW

### Introduction

Glycopyrrolate is an anticholinergic agent used to treat gastrointestinal conditions associated with intestinal spasm and to decrease secretions during anesthesia. Glycopyrrolate has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Glycopyrrolate (glye" koe pir' oh late) is a synthetic quaternary ammonium anticholinergic agent which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, decreasing respiratory and gastrointestinal secretions and intestinal motility. Glycopyrrolate has broad activity against muscarinic acetylcholine receptors, but its highly polar quaternary ammonium group makes it less likely to cross lipid membranes such as the blood brain barrier, which is believed to decrease the potential for central nervous system effects. Glycopyrrolate has been used largely for gastrointestinal conditions including peptic ulcer disease, gastrointestinal spasm and irritable colon. Glycopyrrolate was approved for use in the United States in 1961 but is now not commonly used for gastrointestinal conditions, having been replaced by more effective antiulcer agents. Glycopyrrolate is available in tablets of 1 and 2 mg in several generic forms and under the brand name Robinul. The typically recommended oral dose in adults is 1 to 2 mg two to three times daily. It is also available in a solution for parenteral injection for use during anesthesia and intubation to block vagal reflexes and reduce salivary, tracheal, bronchial and gastric secretions. Common side effects are those of parasympathetic stimulation and include dryness of the mouth and eyes, decreased sweating, headache, visual blurring, constipation, and urinary retention. Because of its structure, glycopyrrolate is believed to be less likely than other anticholinergics to cross the blood brain barrier and cause central nervous system effects such as restlessness, confusion and hallucinations. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Like other anticholinergic agents, glycopyrrolate has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. A major reason for its safety may relate to the low daily dose.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on Anticholinergic Agents.

Drug Class: Gastrointestinal Agents; Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Glycopyrrolate – Generic, Robinul®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Glycopyrrolate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Glycopyrrolate | 596-51-0 | C19-H28-N-O3.Br | Glycopyrrolate Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Glycopyrrolate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Glycopyrrolate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Glycopyrrolate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Glycopyrrolate)